# Pioglitazone

## OVERVIEW

### Introduction

Pioglitazone is an insulin sensitizing agent and thiazolidinedione that is indicated for the treatment of type 2 diabetes. Pioglitazone has been linked to rare instances of acute liver injury.

### Background

Pioglitazone (pye" oh gli' ta zone) is a thiazolidinedione thought to act by engagement of PPAR-γ receptors which induce multiple genes involved in glucose and fatty acid metabolism. In clinical trials, pioglitazone was found to lower blood glucose and HbA1c levels and had additive effects with the sulfonylureas and metformin. Pioglitazone was approved for use in the United States in 1999 and remains in wide use. Current indications for pioglitazone are as an adjunct to diet and exercise to improve glycemic control in adults with type 2 diabetes. While the initial thiazolidinedione approved for use – troglitazone – was associated with high rates of serum aminotransferase elevations and multiple reports of severe liver injury and death from acute liver failure, pioglitazone has been associated with only rare instances of clinically apparent liver injury. Pioglitazone is available in 15, 30 and 45 mg tablets generically and under the brand name Actos, and as a fixed combination with metformin (Actoplus Met and others) and with glimepiride (Duetact and others). The recommended dosage is 15 to 45 mg once daily. Pioglitazone is used as monotherapy as well as in combination with metformin, sulfonylureas or insulin. Common side effects of pioglitazone include weight gain and edema.

### Hepatotoxicity

In contrast to troglitazone, pioglitazone is not associated with an increased frequency of aminotransferase elevations during therapy. In clinical trials, ALT elevations above 3 times the ULN occurred in only 0.26% of patients on pioglitazone, compared to 0.25% of placebo recipients (and 1.9% of troglitazone recipients in similar studies). In addition, clinically apparent liver injury attributed to pioglitazone is very rare, fewer than a dozen cases having been described in the literature despite extensive use of this agent. The liver injury usually arises between 1 and 6 months after starting therapy and all patterns of serum enzymes elevations have been described including hepatocellular, cholestatic and mixed. Allergic phenomena are rare and autoantibodies have not been typically present. Cases of acute liver failure attributed to pioglitazone have been reported, usually in association with a hepatocellular pattern of injury. In most instances, recovery is complete within 2 to 3 months.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury due to pioglitazone is not known, but the general pattern and course differs somewhat from troglitazone and it is unlikely that the thiazolidinediones share a single mechanism for liver injury.

### Outcome and Management

The liver injury from pioglitazone is usually reversed with stopping the medication. Fatal instances of acute liver injury due to pioglitazone have been reported, but are rare. Chronic liver disease and vanishing bile duct syndrome have not been associated with pioglitazone. There exists at least some cross sensitivity to liver injury among the different thiazolidinediones, so that patients with pioglitazone hepatotoxicity should avoid use of rosiglitazone.

References to safety and hepatotoxicity of pioglitazone are given together with references to rosiglitazone and troglitazone in the Overview section on the Thiazolidinediones (updated June 2018).

Drug Class: Antidiabetic Agents

Other Drugs in the Subclass, Thiazolidinediones: Rosiglitazone, Troglitazone

## CASE REPORT

### Case 1. Acute liver injury after 6 months of pioglitazone therapy.

[Modified from: May LD, Lefkowitch JH, Kram MT, Rubin DE. Mixed hepatocellular-cholestatic liver injury after pioglitazone therapy. Ann Intern Med 2002; 136: 449-52. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/11900497)]

A 49 year old man with type 2 diabetes and poor control with glyburide and metformin was started on pioglitazone, which was slowly increased in dose. Six months later he developed jaundice and was found to have elevations in serum aminotransferase and alkaline phosphatase levels (Table). There was no fever, rash or eosinophilia. He had had intermittent nausea and abdominal discomfort during pioglitazone therapy, but liver tests were previously normal. He had no history of liver disease or risk factors for hepatitis. Tests for hepatitis A, B and C were negative as were autoantibodies. A liver biopsy showed cholestasis, portal inflammation and mild bile duct damage suggestive of mixed pattern of injury due to drug hepatotoxicity. Pioglitazone was stopped on admission and he improved rapidly, all tests becoming normal within the following 6 weeks.

#### Key Points

Medication: | Pioglitazone (15-45 mg daily for 6 months)
Pattern: | Mixed (R=2.1)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 6 months
Recovery: | 6 weeks
Other medications: | Metformin, glyburide, lisinopril and omeprazole chronically (continued during admission)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Pre | | 30 | 30 | 0.6
6 months | 0 | 218 | 312 | 5.7 | Pioglitazone stopped
| 3 days | 487 | 617 | 10.4
| 7 days | 665 | 251 | 3.5 | Liver biopsy: mixed injury
6.5 months | 17 days | 372 | 36 | 2.4
7 months | 6 weeks | 30 | 30 | 0.6
Normal Values | | <40 | <116 | < 1.2

* Values estimated from Figure 2 and converted to U/L and mg/dL.

#### Comment

Liver injury first arose after six months of therapy and was not detected early despite serum ALT monitoring. The liver injury was self-limited and recovery was rapid. Jaundice with a mixed pattern of serum aminotransferase elevations is typical of drug induced liver injury in general and occurs frequently, but not invariably, in cases of pioglitazone associated injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pioglitazone – Actos®

DRUG CLASS

Hypoglycemic Agents

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pioglitazone | 112529-15-4 | C19-H20-N2-O3-S.Cl-H | Pioglitazone chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Pioglitazone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(pioglitazone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Pioglitazone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=pioglitazone)